# Emapalumab

## OVERVIEW

### Introduction

Emapalumab is a human monoclonal antibody to interferon gamma which acts to block its binding to cell surface receptors and activation of inflammatory signals. Emapalumab is used to treat the severe inflammatory condition of hemophagocytic lymphohistiocytosis (HLH) in which serum gamma interferon levels are elevated. Emapalumab therapy is associated with mild and transient serum enzyme elevations during therapy, but has not been linked to instances of clinically apparent acute liver injury.

### Background

Emapalumab (em" a pal' ue mab) is a recombinant, human IgG1 monoclonal antibody to gamma interferon, which inhibits its binding to cell surface interferon receptors and the subsequent activation of intracellular proinflammatory signaling pathways. Gamma interferon levels are known to be elevated in patients with hemophagocytic lymphohistiocytosis (HLH), a life-threatening inflammatory syndrome marked by fever, enlargement of liver and spleen, macrophage update of red blood cells (hemophagocytosis) in bone marrow, spleen and lymph nodes, low natural killer cell activity and high levels of serum ferritin, triglycerides and multiple cytokines. HLH has primary genetic causes but can also arise secondarily as a complication of viral infections, cancer, severe rheumatic diseases and immunosuppression after transplantation. In clinical trials, emapalumab was found to reduce hemolysis and the need for blood transfusions with subsequent improvement in symptoms and quality of life in children and adults with recurrent HLH. Emapalumab was approved for use in HLH in the United States in 2018. Emapalumab is available as a solution in single dose vials of 10 mg in 2 mL or 50 mg in 10 mL (5 mg/mL) under the commercial name Gamifant. The recommended starting dose is 1 mg/kg as an intravenous infusion twice per week. Doses can be modified based upon clinical and laboratory results and therapy continued until hematopoietic cell transplantation, or unacceptable toxicity or until it is no longer thought to be needed. Premedication with dexamethasone is recommended as is prophylaxis for herpes zoster, Pneumocystis jirovecii and fungal infections. Side effects can include infusion site reactions, infections, fever and hypertension. Uncommon severe complications include severe infusion reactions and severe infections, including reactivation of tuberculosis, herpes zoster, pneumocystis jirovecii and fungal infections. Generally, however, the symptoms and complications of the underlying HLH overshadow the adverse effects of inhibition of gamma interferon.

### Hepatotoxicity

In clinical trials of emapalumab in patients with HLH, serum enzymes were usually elevated before therapy as a part of the underlying the hyperinflammatory condition. In the small number of patients treated, there was little evidence of hepatotoxicity, serum enzyme elevations generally being transient and rising only slightly above baseline elevated levels. There have been no reports of clinically apparent liver injury with jaundice attributed to emapalumab therapy in patients with HLH. Because in blocks interferon gamma signaling, it may cause reactivation of microbial organisms that are ordinarily modulated by interferon gamma-induced cytokines or intracellular proteins. Reactivation of tuberculosis, pneumocystis jirovecii, herpes zoster and fungal infections but not hepatitis B or C are listed as potential complications of therapy. In preregistration clinical trials, there were no reports of reactivation of hepatitis B and none have been published since the introduction of emapalumab therapy into clinical practice.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which emapalumab might cause liver injury is unknown. Emapalumab is a monoclonal antibody and, like other proteins, is metabolized into amino acids and is unlikely to have intrinsic toxicity.

### Outcome and Management

Emapalumab therapy has been linked to instances of mild, transient serum enzyme elevations during therapy, typically arising a few weeks after an initial or an early infusion of the monoclonal antibody. These elevations are typically mild and self-limiting and rarely require dose modification. Neverthelss, routine pre-screening as well as on-therapy monitoring of renal, electrolyte and hepatic function is recommended. In patients who develop persistent marked elevations of serum ALT or alkaline phosphatase or who develop jaundice and symptoms, therapy should be interrupted at least until levels return to or near baseline values. Restarting emapalumab should be done with caution and continued monitoring.

Drug Class: Hematologic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Emapalumab – Gamifant®

DRUG CLASS

Hematologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Emapalumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Emapalumab | 1709815-23-5 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 12 April 2019

Abbreviations used: HLH, hemophagocytic lymphohistiocytosis.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999; well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of monoclonal antibodies used as immunosuppressive agents; mentions rituximab and problems of reactivation of hepatitis B, but also states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists"; emapalumab is not specifically mentioned).
Krensky AM, Azzi JR, Hafler DA. Immunosuppressants and toleragens. In, Brunton LL, Hilal-Dandan R, Knollmann BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 637-54. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that liver enzyme elevations were present in almost all subjects who received emapalumab as therapy for primary HLH and levels increased in a proportion during treatment, but the elevations were usually minimally above baseline and none required early discontinuation of treatment; in studies in normal volunteers, emapalumab was associated with mild aminotransferase elevations during treatment that were rarely above twice normal and always resolved once the infusions were stopped).
Morimoto A, Nakazawa Y, Ishii E. Hemophagocytic lymphohistiocytosis: pathogenesis, diagnosis, and management. Pediatr Int 2016; 58: 817-25. (Review of the clinical features, diagnosis, etiology, natural history and management of HLH before the availability of emapalumab). 27289085
Esteban YM, de Jong JLO, Tesher MS. An overview of hemophagocytic lymphohistiocytosis. Pediatr Ann 2017; 46: e309-e313. (Review of the causes, clinical features, diagnosis and management of HLH). 28806468
Lounder DT, Bin Q, de Min C, Jordan MB. Treatment of refractory hemophagocytic lymphohistiocytosis with emapalumab despite severe concurrent infections. Blood Adv 2019; 3: 47-50. (Case report of a child with primary HLH with severe complications and multiorgan failure who received emapalumab on a compassionate use basis [for 14 weeks] and had a dramatic response, beginning within days of starting infusions and resulting in a complete remission that was maintained for several years after all therapy was stopped). 30617216
Al-Salama ZT. Emapalumab: first global approval. Drugs 2019; 79: 99-103. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, toxicity and current ongoing evaluation of emapalumab shortly after its approval in the US as therapy of primary HLH). 30623346

## OTHER REFERENCE LINKS

1. Recent References on Emapalumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Emapalumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Emapalumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Emapalumab)